# Inavolisib

## OVERVIEW

### Introduction

Inavolisib is a small molecule inhibitor of phosphatidylinositol 3-kinase and is used in combination with other antineoplastic agents to treat selected adults with locally advanced or metastatic breast cancer. Inavolisib is associated with transient elevations in serum aminotransferase levels during therapy but has not been linked to episodes of clinically apparent liver injury with jaundice.

### Background

Inavolisib (in a voe’ li sib) is an orally available, specific inhibitor of phosphatidylinositol 3-kinase (PIK3) that is used in the therapy of advanced or metastatic breast cancer that has PIK3 catalytic alpha subunit p110α (CA) mutations and is hormone receptor (HR) positive and human epidermal growth factor receptor 2 (HER2) negative. The mutated, rearranged PIK3-CA is found in 35% to 40% of cases of advanced or metastatic HR-positive breast cancer and is associated with a poor prognosis and resistance to standard PIK3 inhibitors. In cell lines, inavolisib induced apoptosis in PIK3-CA mutated breast cancer cell lines. Inavolisib also demonstrated antitumor activity in animal xenograft models of breast cancer with PIK3-CA mutations. In a large, controlled trial, patients with HR-positive and HER2-negative advanced or metastatic breast cancer harboring PIK3-CA mutations were treated with the combination of palbociclib and fulvestrant with either inavolisib or placebo in 28 day cycles. The median progression-free survival was superior with inavolisib (15 months) compared to placebo (7.3 months). Inavolisib was approved in 2024 in the United States as treatment for patients with locally advanced or metastatic HR-positive, HER2-negative breast cancer with mutations in PIK3-CA. Inavolisib is available in tablets of 3 and 9 mg under the brand name Itovebi. The recommended dose is 9 mg once daily until unacceptable toxicity or disease progression arises. Side effects are common and include mild-to-moderate stomatitis, diarrhea, fatigue, nausea, anorexia, and rash. Laboratory abnormalities can include increases in fasting glucose, creatinine, and serum aminotransferases, as well as decreases in neutrophils, lymphocytes, hemoglobin, platelet counts, calcium, magnesium, potassium, and sodium. Less frequent but potentially severe adverse events include severe hyperglycemia, stomatitis, diarrhea, and embryo-fetal toxicity.

### Hepatotoxicity

In the prelicensure trials of inavolisib in combination with palbociclib and fulvestrant as therapy of advanced or metastatic breast cancer, liver test abnormalities were frequent, with elevations in ALT levels in 34% compared to 29% of those on placebo with palbociclib and fulvestrant. The enzyme elevations were usually transient, mild-to-moderate in severity and not associated with symptoms or jaundice. ALT elevations above 5 times the upper limit of normal (ULN) arose in 3% vs 1.2% with placebo. Because inavolisib was always given in combination with other kinase inhibitors and hormonal agents, it was difficult to attribute the liver test abnormalities to inavolisib alone. There were no discontinuations of inavolisib because of liver test abnormalities and no episodes of clinically apparent liver injury or deaths from liver failure. Since approval and clinical availability of inavolisib, there have been no published case reports of clinically apparent liver injury with jaundice, but clinical experience with its use has been limited.

Likelihood score: E* (unproven but suspected rare cause of clinically apparent liver injury).

### Mechanism of Injury

The causes of serum enzyme elevations or liver injury from inavolisib therapy are possibly due to direct toxicity of the kinase inhibition of PIK3. Inavolisib is primarily metabolized by hydrolysis and minimally metabolized by the hepatic microsomal enzyme CYP3A. For these reasons, clinically significant drug-drug interactions are unlikely.

### Outcome and Management

The product label for inavolisib does not recommend monitoring of liver tests during therapy. If serum aminotransferase elevations above 5 times the upper limit of normal are identified or if any elevations are accompanied by jaundice or symptoms, therapy should be at least temporary discontinued. There is no evidence to suggest a cross reactivity in risk for adverse events, hypersensitivity, or hepatic injury between inavolisib and other kinase inhibitors used to treat breast cancer, such as palbociclib, alpelisib, ribociclib, and capivaseritib.

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

Other Kinase Inhibitors Used for Breast Cancer: Alpelisib, Capivaseritib, Ribociclib, Talazoparib, Tucatinib

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Inavolisib – Itovebi®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Inavolisib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Inavolisib | 2060571-02-8 | C18H19F2N5O4

## ANNOTATED BIBLIOGRAPHY

References updated: 05 April 2025

Abbreviations: HER2, human epidermal growth factor receptor 2; HR, hormone receptor; PIK3, phosphatidylinositol-3-kinase; PIK3-CA, PIK3 catalytic alpha subunit p110α; PTEN, phosphatase and tensin homolog; ULN, upper limit of the normal range.

Zimmerman HJ. Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of tyrosine kinase inhibitors such as inavolisib).
DeLeve LD. Erlotinib. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents discusses several tyrosine kinase inhibitors including imatinib, gefitinib, erlotinib and crizotinib, but not inavolisib).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway-targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
FDA. Multi-Discipline Review. 2024. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2024/219249Orig1s000MultidisciplineR.pdf (FDA review of the data on efficacy and safety of inavolisib in support of its approval for advanced or metastatic breast cancer in the US, mentions that liver test abnormalities were frequent in patients who received palbociclib and fulvestrant both with vs without inavolisib, ALT elevations arising in 19.1% vs 18.5% which were above 5 times the upper limit of normal (ULN) in 3.7% vs 1.9%, but that there were no instances of clinically apparent liver injury with jaundice or life-threatening or fatal liver injury).
Spraggs CF, Xu CF, Hunt CM. Genetic characterization to improve interpretation and clinical management of hepatotoxicity caused by tyrosine kinase inhibitors. Pharmacogenomics 2013; 14: 541-54. (Review of genetic associations of serum ALT and bilirubin elevations during therapy with tyrosine kinase inhibitors focusing on lapatinib and pazopanib; inavolisib is not discussed). 23556451
Shah RR, Morganroth J, Shah DR. Hepatotoxicity of tyrosine kinase inhibitors: clinical and regulatory perspectives. Drug Saf 2013; 36: 491-503. (Review of the hepatotoxicity of 18 tyrosine kinase inhibitors approved for use in cancer in the US as of 2013, before the availability of inavolisib which is not discussed). 23620168
Hanan EJ, Braun MG, Heald RA, MacLeod C, Chan C, Clausen S, Edgar KA, et al. Discovery of GDC-0077 (inavolisib), a highly selective inhibitor and degrader of mutant PI3Kα. J Med Chem. 2022;65:16589-16621. (Description of the optimization and characterization of a competitive inhibitor of PIK3-CA mutants [GDC-0077, inavolisib], which induces protein degradation of the mutant protein and relatively spares wild type PIK3-CA as well as other PIK3 isoforms in human breast cancer cells). 36455032
Sriravindrarajah A, Hurwitz J, Lim E, Greenfield JR. Hyperglycemia secondary to phosphatidylinositol-3 kinase (PI3K) inhibition. Endocrinol Diabetes Metab Case Rep. 2024;2024:24-0040. (63 year old woman with metastatic breast cancer and renal disease but normal fasting blood glucose and HbA1c levels developed severe hyperglycemia [glucose 439 mg/dL] within 2 weeks of starting inavolisib [9 mg daily] and fulvestrant that was not controlled until the dose was reduced to 3 mg daily and that resolved completely once the PIK3-CA inhibitor was stopped). 39437820
Turner NC, Im SA, Saura C, Juric D, Loibl S, Kalinsky K, Schmid P, et al. Inavolisib-based therapy in PIK3CA-mutated advanced breast cancer. N Engl J Med. 2024;391:1584-1596. (Among 325 women with advanced or metastatic HR-positive, HER2-negative breast cancer with PIK3-CA mutations treated with palbociclib and fulvestrant with inavolisib [9 mg daily] vs placebo, the objective response rate was 58% vs 25% and median progression-free survival 15 vs 7.3 months, while adverse events arose in 99% vs 100% that were severe in 58% vs 25%, most frequently neutropenia [89% vs 91%], stomatitis [51% vs 27%], hyperglycemia [59% vs 9%], diarrhea [48% vs 16%], and rash [25% vs 17%], leading to early discontinuation in 7% vs 1%; no mention of ALT elevations or hepatotoxicity). 39476340
Inavolisib (Itovebi) for locally advanced or metastatic breast cancer. Med Lett Drugs Ther. 2024;66:e186-e187. (Brief review of the mechanism of action, clinical efficacy, safety, and costs of inavolisib shortly after its approval as therapy of breast cancer in the US, mentions side effects of hyperglycemia, stomatitis, fatigue, nausea, decreased appetite, diarrhea, and hematologic toxicity but does not mention ALT elevations or hepatotoxicity). 39509160
Jhaveri KL, Accordino MK, Bedard PL, Cervantes A, Gambardella V, Hamilton E, Italiano A, et al. Phase I/Ib trial of inavolisib plus palbociclib and endocrine therapy for PIK3CA-mutated, hormone receptor-positive, human epidermal growth factor receptor 2-negative advanced or metastatic breast cancer. J Clin Oncol. 2024;42:3947-3956. (Among 53 patients with advanced or metastatic breast cancer harboring PIK3-CA mutations who were treated with inavolisib with palbociclib and either fulvestrant or letrozole, adverse events arose in all patients and were mainly stomatitis, hyperglycemia, neutropenia, diarrhea, thrombocytopenia, leukopenia, asthenia, alopecia, and rash; no mention of ALT elevations or hepatotoxicity). 39236276
Blair HA. Inavolisib: first approval. Drugs. 2025;85:271-278. (Review of the mechanism of action, history of development, pharmacology, clinical efficacy, and safety of inavolisib shortly after its approval for use in the US, states that inavolisib has “a manageable tolerability profile” and makes no mention of ALT elevations or hepatotoxicity). 39873916

## OTHER REFERENCE LINKS

1. Recent References on Inavolisib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Inavolisib+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Inavolisib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Inavolisib)